# Bupropion

## OVERVIEW

### Introduction

Bupropion is an aminoketone antidepressant that is widely used in therapy of depression and smoking cessation. Bupropion therapy can be associated with transient, usually asymptomatic elevations in serum aminotransferase levels and has been linked to rare instances of clinically apparent acute liver injury.

### Background

Bupropion (bue proe' pee on) is an aminoketone derivative and antidepressant whose mechanism of action is not well understood. Bupropion has no activity against monamine oxidase and only weak inhibition of serotonin and norepinephrine reuptake. It appears to act via noradrenergic or dopaminergic mechanisms. Bupropion was approved for use in moderate and severe depression in the United States in 1985 and was later approved for use in seasonal affective disorder and in aiding smoking cessation. Bupropion is currently in wide use, approximately 4 million prescriptions being filled yearly. Bupropion is available as immediate and sustained release tablets of 75, 100, 150, 200 and 300 mg in several generic forms and under the brand name of Welbutrin. The recommended dosage for depression in adults is 75 to 300 mg daily either twice daily in immediate release forms or once daily in extended or sustained release forms. Separate formulations of sustained release forms are available for smoking cessation in tablets of 150 mg generically and under the brand name Zyban, recommended dosage being 150 to 300 mg daily. Common side effects of bupropion are drowsiness, dizziness, agitation, headahce, nausea, abdominal pain and dry mouth.

### Hepatotoxicity

Liver test abnormalities have been reported to occur in less than 1% of patients on bupropion, and elevations are usually modest and usually do not require dose modification or discontinuation. Rare instances of acute, clinically apparent episodes of liver injury with marked liver enzyme elevations with or without jaundice have been reported in patients on bupropion (Case 1). The onset of injury is usually within 1 to 3 months and the pattern of serum enzyme elevations has been variable, from hepatocellular to cholestatic. Autoimmune (autoantibodies) are found in a proportion of cases, but in low titer. Immunoallergic features (rash, fever, eosinophilia) are uncommon. The injury is generally self-limited, but fatal cases have been reported.

Likelihood score: C (probable rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which bupropion causes liver injury is not known. Bupropion is extensively metabolized by the liver, mainly via the cytochrome P450 system (CPY2B6), and hepatotoxicity may be mediated by toxic intermediates of their metabolism.

### Outcome and Management

The serum aminotransferase elevations that occur on bupropion therapy are usually self-limited and do not require dose modification or discontinuation of therapy. Rare instances of acute liver failure and chronic hepatitis have been attributed to bupropion therapy. Persons with intolerance to bupropion may have similar reactions to other antidepressants, and careful monitoring is warranted if other such agents are used.

Drug Class: Antidepressant Agents

## CASE REPORT

### Case 1. Acute liver injury due to bupropion.

[Modified from: Carlos Titos-Arcos J, Hallal H, Collados V, Plaza-Aniorte J. [Acute hepatitis secondary to bupropion]. Gastronterol Hepatol 2008; 31: 549. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/18928762)]

A 48 year old man with chronic alcoholism being treated with disulfiram and naltrexone for alcohol addiction developed jaundice and fatigue 4 weeks after having bupropion added to his treatment regimen. He was jaundiced but had no fever or rash. Laboratory tests showed prominent elevations in both serum aminotransferases and alkaline phosphatase and a total bilirubin of 12.1 mg/dL. Bupropion was discontinued and he began to improve (Table). Tests for hepatitis A, B and C were negative. He had low levels of antinuclear antibody (ANA 1:80) and antimitochondrial antibody (AMA 1:80), but no smooth muscle antibody. An abdominal ultrasound showed no evidence of biliary obstruction. Within 3 months of stopping bupropion, serum enzymes and bilirubin levels had returned to baseline; the continued low level abnormal values during long term follow up were attributed to alcohol use. Serum ANA and AMA were negative.

#### Key Points

Medication: | Bupropion
Pattern: | Mixed (R=3.9)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 1 month
Recovery: | 2-3 months
Other medications: | Naltrexone, disulfiram

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | Pre | 86 | 182 | 0.9 | Alcohol withdrawl
4 weeks | 0 | 1405 | | | Bupropion stopped
| 3 days | 1075 | 803 | 12.1
| 5 days | 889 | 708 | 6.4
5 weeks | 7 days | 561 | 324 | 3.6
| 9 days | 271 | 317 | 1.3
3 months | 2 months | 43 | 184 | 0.4
7 months | 6 months | 62 | 185 | 1.0
1 year | 1 year | 40 | 190 | 0.7
2 years | 2 years | 67 | 178 | 0.8
Normal Values | | <40 | <115 | <1.2

#### Comment

Bupropion is a commonly used antidepressant which is also used in therapy of smoking cessation. Liver enzyme elevations during bupropion therapy occur in less than 1% of patients and only rare instances of clinically apparent liver injury have been attributed to bupropion. In this instance, as with many case reports on bupropion, the patient had an underlying liver disease (suspected to be alcoholic liver disease), but the clinical presentation was unlikely due to alcoholism. The role of disulfiram was not discussed in the case report, but it is a well known cause of acute liver injury and its role in this case of an acute “mixed” hepatitis cannot be excluded.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Bupropion – Wellbutrin®

DRUG CLASS

Antidepressant Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=bupropion)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Bupropion | 34911-55-2 | C13-H18-Cl-N-O | Image of Bupropion Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 11 September 2017

Zimmerman HJ. Antidepressants. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 493-8. (Expert review of hepatotoxicity published in 1999; bupropion listed in a table as a rare cause of hepatocellular injury).
Larrey D, Ripault M-P. Bupropion. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 451. (Review of hepatotoxicity of antidepressants mentions that bupropion is considered very safe but that cases of liver injury have been reported during the post-marketing period including two cases of liver failure).
O'Donnell JM, Shelton RC. Drug therapy of depression and anxiety disorders. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 397-416. (Textbook of pharmacology and therapeutics; bupropion appears to act via multiple mechanisms involving norepinephrine and dopamine).
Tucker WE Jr. Preclinical toxicology of bupropion: an overview. J Clin Psychiatry 1983; 44: 60-62. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/%206406465) (In chronic dosing of animals there were slight to moderate increases in ALT and Alk P levels and 13% of animals developed focal nodular hyperplasia; no liver cancer).
Fleet JVW, Manberg PJ, Miller LL, Harto-Truax N, Sato T, Fleck RJ, Stern WC, et al. Overview of clinically significant adverse reactions to bupropion. J Clin Psychiatry 1983; 44 (Sec 2): 191-6. [Not in PubMed] (Pooled data on 1153 patients treated with bupropion; “Elevated liver enzymes occasionally found during chronic administration of high doses of bupropion in animals were not seen during short- or long term treatment with therapeutic doses in humans”).
Oslin DW, Duffy K. The rise of serum aminotransferases in a patient treated with bupropion. J Clin Psychopharmacol. 1993; 13: 364-5. (73 year old woman developed ALT elevations [5.4 times ULN] 54 days after starting bupropion, falling to normal within 10 days of stopping and recurring within 4 days with rechallenge [ALT 3.6 times ULN]). 8227497
Grohmann R, Rüther E, Engel RR, Hippius H. Assessment of adverse drug reactions in psychiatric inpatients with the AMSP drug safety program: methods and first results for tricyclic antidepressants and SSRI. Pharmacopsychiatry 1999; 32: 21-8. (Analysis of reporting of adverse events among pscyhiatric inpatients in 29 German hospitals between 1993 to 1997; 896 severe adverse events among 48,564 patients [1.8%], both total and hepatic events were more common with tricyclics than SSRIs). 10071179
Hu KQ, Tiyyagura L, Kanel G, Redeker AG. Acute hepatitis induced by bupropion. Dig Dis Sci 2000; 45: 1872-3. (41 year old man with chronic hepatitis C developed fever and malaise 41 days after starting bupropion [bilirubin 3.8 mg/dL, ALT 6660 U/L, Alk P 232 U/L, INR 1.7], resolving rapidly on stopping). 11052334
Alvaro D, Onetti-Muda A, Moscatelli R, Atili AF. Acute cholestatic hepatitis induced by bupropion prescribed as pharmacological support to stop smoking. A case report. Dig Liver Dis 2001; 33: 703-6. (49 year old woman developed jaundice one month after starting bupropion for smoking cessation [bilirubin 7.4 rising to 27.4 mg/dL, ALT 29 times ULN, Alk P 3 times ULN, ANA 1:80], improving with corticosteroid therapy and resolving within 50 days of stopping drug). 11785718
Carvajal Garcia-Pando A, Garrcia del Pozo J, Sanchez A, Velasco M, Rueda de Castro A, Lucena MI. Hepatotoxicity associated with the new antidepressants. J Clin Psychiatry 2002; 63: 135-7. (Analysis of cases of hepatotoxicity from antidepressants in Spanish Pharmacovigilance System from 1989-1999, identified 99 cases; among SSRIs, 26 due to fluoxetine, 14 paroxetine, 6 fluvoxamine, 5 sertraline, 3 venlafaxine and 2 citalopram; among tricyclics, 16 clomipramine, 7 amitriptyline, 6 imipramine; among miscellaneous, 3 nefazodone and 1 trazodone; but all similar in rate ~1-3 per 100,000 patient-years of exposure, except for nefazodone=29/100,000; bupropion not mentioned). 11874214
Lucena M, Carvajal A, Andrade R, Velasco A. Antidepressant-induced hepatotoxicity. Expert Opin Drug Saf 2003; 2: 249-62. (Review of hepatotoxicity of antidepressants; antidepressant use has increased markedly between 1992 and 2002, accounting for 5% of cases of hepatotoxicity; SSRIs are less likely to cause injury than tricyclics and MAO inhibitors; range of presentations, typically self-limited and rapid recovery; no hallmarks of hypersensitivity; bupropion not mentioned). 12904104
Bagshaw SM, Cload B, Gilmour J, Leung ST, Bowen TJ. Drug-induced rash with eosinophilia and systemic symptoms syndrome with bupropion administration. Ann Allergy Asthma Immunol 2003; 90: 572-5. (24 year old man developed fever, rash and eosinophilia [10%] 21 days after starting bupropion, with subsequent relapsing course, developing jaundice on day 40 [bilirubin 3.1 mg/dL, ALT 4040 U/L, Alk P 388 U/L, ANA 1:40], possible renal and pulmonary involvement, but ultimate improvement on corticosteroids). 12775141
Khoo A-L, Tham L-S, Lee K-H, Lim G-K. Acute liver failure with concurrent bupropion and carbimazole therapy. Ann Pharmacother 2003; 37: 220-3. (41 year old man developed jaundice and acute liver failure 10 weeks after stopping 10 day course of bupropion while also on long term carbimazole [bilirubin 29 rising to 84 mg/dL, ALT 674 U/L, Alk P 138 U/L, protime rising to 42.4 sec], dying of hepatic failure 11 days after admission). 12549952
Boshier A, Wilton LV, Shakir SA. Evaluation of the safety of bupropion (Zyban) for smoking cessation from experience gained in general practice use in England in 2000. Eur J Clin Pharmacol 2003; 59: 767-73. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/14615857) (Among 11,735 patients started on bupropion for smoking cessation on whom follow up was obtained by questionnaire from the prescribing physician, adverse events were reported in 350 [3%], but were mostly mild, nonspecific symptoms of insomnia, nausea, and dizziness; no mention of jaundice, hepatitis or death from liver injury).
Degner D, Grohmann R, Kropp S, Rüther E, Bender S, Engel RR, Schmidt LG. Severe adverse drug reactions of antidepressants: results of the German multicenter drug surveillance program AMSP. Pharmacopsychiatry 2004; 37 Suppl 1: S39-45. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/15052513) (Analysis of adverse drug reactions reported from 1993-2000 in 35 psychiatric hospitals; 0.7% of SSRI recipients had a severe adverse event; hepatic in 0.05%).
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants done in the US between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, only four being due to antidepressants: nefazodone [2], bupropion [1], and paroxetine [1]). 15390328
Andrade RJ, Lucena MI, Fernández MC, Pelaez G, Pachkoria K, García-Ruiz E, García-Muñoz B, et al.; Spanish Group for the Study of Drug-Induced Liver Disease. Drug-induced liver injury: an analysis of 461 incidences submitted to the Spanish registry over a 10-year period. Gastroenterology 2005; 129: 512-21. (Reports to a Spanish network found 461 cases of drug induced liver disease; antidepressants accounted for 23 cases [5%]). 16083708
Björnsson E, Olsson R. Suspected drug-induced liver fatalities reported to the WHO database. Dig Liver Dis 2006; 38: 33-8. (Survey of drug induced liver fatalities reported to WHO database between 1968-2003 revealed 4690 reports; no antidepressant ranked among the top 21 agents that were linked to at least 50 cases each) . 16054882
Sabaté M, Ibáñez L, Pérez E, Vidal X, Buti M, Xiol X, Mas A, et al. Risk of acute liver injury associated with the use of drugs: a multicentre population survey. Aliment Pharmacol Ther 2007; 25: 1401-9. (Among 126 cases of drug induced liver injury seen in Spain between 1993-2000, 3 were attributed to paroxetine and 3 to fluoxetine with a relative risk of injury to rate of use in the population of 3.0 and 1.8 respectively). 17539979
DeSanty KP, Amabile CM. Antidepressant-induced liver injury. Ann Pharmacother 2007; 41: 1201-11. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/17609231) (Review of antidepressant induced liver injury mentions that no cases of liver failure occurred during clinical trials of bupropion and elevated liver enzymes occurred in 0.1-1.0% of recipients, but that 5 cases of acute liver injury attributed to bupropion have been published, several of which were quite convincing).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, 6 were attributed to duloxetine, 3 to atomoxetine, 2 to fluoxetine, 2 to bupropion, and 1 to sertraline as single agents). 18955056
Carlos Titos-Arcos J, Hallal H, Collados V, Plaza-Aniorte J. [Acute hepatitis secondary to bupropion]. Gastronterol Hepatol 2008; 31: 549. (48 year old man developed jaundice 1 month after starting bupropion [bilirubin 12.1 mg/dL, ALT 1405 U/L, Alk P 803 U/L, ANA 1:80], resolving within 3 months of stopping: Case 1). 18928762
Humayun F, Shehab TM, Tworek JA, Fontana RJ. A fatal case of bupropion (Zyban) hepatotoxicity with autoimmune features: Case report. J Med Case Reports 2007; 1: 88. (55 year old man developed jaundice 6 months after starting bupropion for smoking cessation [bilirubin 5.3 rising to 22.7 mg/dL, ALT 1459 U/L, Alk P 219 U/L, ANA 1:160], responding to prednisone therapy but relapsing when it was stopped, with progressive liver failure and death 105 days after onset). 17877816
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, 3 of which were linked to antidepressants: one each for nefazodone, fluoxetine and venlafaxine). 20949552
Alonso Rodríguez L, Barcina Pajares R, Fuentes Vigil J, Gutiérrez González A, Rodríguez Pérez L. [Acute toxic hepatitis secondary to a single dose of bupropion]. Gastroenterol Hepatol 2010; 33: 547-9. Spanish. (59 year old man developed abdominal pain 24 hours after a single 150 mg dose of bupropion [bilirubin 1.6 rising to 8.7 mg/dL, ALT 1116 U/L, Alk P 146 U/L], resolving rapidly within 3 weeks). 20435378
Park SH, Ishino R. Liver injury associated with antidepressants. Curr Drug Saf 2013; 8: 207-23. (Review of drug induced liver injury due to antidepressants; no discussion of bupropion). 23914755
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver iInjury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, none of which were attributed to bupropion). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases; one was attributed to amitryptilline, but none were attributed to buproprion or other antidepressants). 24552865
Voican CS, Corruble E, Naveau S, Perlemuter G. Antidepressant-induced liver injury: a review for clinicians. Am J Psychiatry 2014; 171: 404-15. (Review of hepatotoxicity of antidepressants, mentions that 7 cases of hepatocellular and cholestatic hepatitis have been reported with bupropion, despite infrequency of ALT elevations and absence of clinical cases during clinical trials). 24362450
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 20 cases were attributed to antidepressant medications including 4 to bupropion). 25754159
Tang DM, Koh C, Twaddell WS, von Rosenvinge EC, Han H. Acute hepatocellular drug-induced liver injury from bupropion and doxycycline. ACG Case Rep J 2015; 3: 66-8. (29 year old man developed jaundice 14 days after starting doxycycline and bupropion [bilirubin 19.9 mg/dL, ALT 896 U/L, Alk P 234 U/L, INR 3.0], with resolution within 2 months of stopping both drugs and with prednisone therapy). 26504884

## OTHER REFERENCE LINKS

1. Recent References on Bupropion: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=bupropion+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Bupropion: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=bupropion)